# Eslicarbazepine

## OVERVIEW

### Introduction

Eslicarbazepine is an aromatic anticonvulsant similar to oxcarbazepine that is used in combination with other antiepileptic agents as therapy of partial onset seizures. Eslicarbazepine is associated with a low rate of transient serum enzyme elevations during therapy and has been implicated in rare instances of clinically apparent liver injury.

### Background

Eslicarbazepine (es" li kar baz' e peen) is an aromatic anticonvulsant related in structure and activity to oxcarbazepine. Its mechanism of action is unknown but, like other carboxamides, eslicarbazepine is believed to inhibit voltage-gated sodium channels and thereby slow neurotransmission and interrupt the rapid, repetitive firing that is characteristic of epilepsy. Eslicarbazepine was approved for use in the United States in 2013 as an anticonvulsant to be used alone or in combination with other agents in the therapy of partial onset seizures. Eslicarbazepine is available in tablets of 200, 400, 600 and 800 mg under the brand name Aptiom. The recommended initial dose in adults is 400 mg once daily, which can be increased to 800 to 1600 mg once daily based upon tolerance and effect. The recommended initial doses in children are 200 to 400 mg once daily based upon body weight with maintenance dosages ranging from 400 to 1200 mg. Side effects may include headache, dizziness, ataxia, blurred vision, nausea, fatigue and tremor. Rare, but potentially serious adverse events include hyponatremia, suicidal ideation or behavior and hypersensitivity reactions including DRESS and Stevens Johnson syndrome.

### Hepatotoxicity

In prelicensure clinical trials, addition of eslicarbazepine to standard anticonvulsant therapy was reported to be associated with ALT elevations above 3 times the upper limit of normal (ULN) in a small proportion of patients (<1.0%). A single case of hepatitis with jaundice during eslicarbazepine therapy was also reported. Since approval, there have been rare isolated reports of clinically apparent liver injury associated with eslicarbazepine used, but the clinical features suggested that hepatic ischemia or other anticonvulsants combined with eslicarbazepine may have been responsible. The onset was within a few days to several months after starting the anticonvulsant, and the presentation was characterized by a hepatocellular pattern of serum enzyme elevations, one case being asymptomatic and mild and the other severe. In both instances there was rapid recovery.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Eslicarbazepine is metabolized by the liver, largely by CYP 2C19, but has not been reported to have significant drug interactions. The mechanism of hepatic injury from eslicarbazepine is not known, but may relate to a toxic or immunogenic metabolite.

### Outcome and Management

Most instances of liver injury associated with eslicarbazepine have been transient and mild but more severe cases have been reported. The product label recommends baseline evaluation of liver tests and prompt discontinuation if jaundice or symptoms of liver disease arise. There is no information on the possible cross sensitivity to hepatotoxicity between eslicarbazepine and other anticonvulsants, but its structure would suggest that it would havel cross sensitivity to hypersensitivity reactions with oxcarbazepine and possibly partial cross sensitivity to other aromatic anticonvulsants such as phenytoin, carbamazepine and lamotrigine.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eslicarbazepine – Aptiom®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Eslicarbazepine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Eslicarbazepine | 104746-04-5 | C15-H14-N2-O2 | Eslicarbazepine chemical structure
Oxcarbazepine | 28721-07-5 | C15-H12-N2-O2 | Oxcarbazepine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 14 February 2018

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999 before the availability of eslicarbazepine).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; eslicarbazepine is not discussed).
McNamara JO. Pharmacotherapy of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, p. 602. (Textbook of pharmacology and therapeutics).
Galindo PA, Borja J, Gómez E, Mur P, Gudín M, García R, Encinas C, et al. Anticonvulsant drug hypersensitivity. J Investig Allergol Clin Immunol 2002; 12: 299-304. (Among 15 patients with cutaneous hypersensitivity reactions to anticonvulsants [9 accompanied by liver test elevations] which were caused by carbamazepine [n=8], phenytoin [5], lamotrigine [4], phenobarbital [4], valproate [1] and felbamate [1], eslicarbazepine and oxcarbazepine were not mentioned). 12926190
Elger C, Halász P, Maia J, Almeida L, Soares-da-Silva P; BIA-2093-301 Investigators Study Group. Efficacy and safety of eslicarbazepine acetate as adjunctive treatment in adults with refractory partial-onset seizures: a randomized, double-blind, placebo-controlled, parallel-group phase III study. Epilepsia 2009; 50: 454-63. (Among 402 patients with partial onset seizures treated with adjunctive eslicarbazepine [400, 800 or 1200 mg daily] or placebo for 12 weeks, there were no “clinically relevant findings” in the clinical laboratory parameters). 19243424
Halász P, Cramer JA, Hodoba D, Członkowska A, Guekht A, Maia J, Elger C, et al.; BIA-2093-301 Study Group. Long-term efficacy and safety of eslicarbazepine acetate: results of a 1-year open-label extension study in partial-onset seizures in adults with epilepsy. Epilepsia 2010; 51: 1963-9. (Among 314 patients with poorly controlled partial onset seizures who completed a placebo controlled study of eslicarbazepine and were maintained on therapy [600 to 1600 mg daily] for 52 weeks, common side effects were headache, dizziness, diplopia and somnolence; 3 patients developed rash, and “review of changes in clinical laboratory parameters did not reveal clinically relevant findings”). 20662896
Ben-Menachem E, Gabbai AA, Hufnagel A, Maia J, Almeida L, Soares-da-Silva P. Eslicarbazepine acetate as adjunctive therapy in adult patients with partial epilepsy. Epilepsy Res 2010; 89 (2-3): 278-85. (Among 395 adults with poorly controlled partial onset seizures given eslicarbazepine [400, 800 or 1200 mg daily] or placebo once daily for 14 weeks, seizure control was greater with the two higher doses of eslicarbazepine and side effects included dizziness, somnolence, headache, ataxia, diplopia, blurred vision, nausea and fatigue; there were no “clinically relevant findings” in clinical laboratory parameters). 20299189
Gil-Nagel A, Elger C, Ben-Menachem E, Halász P, Lopes-Lima J, Gabbai AA, Nunes T, et al. Efficacy and safety of eslicarbazepine acetate as add-on treatment in patients with focal-onset seizures: integrated analysis of pooled data from double-blind phase III clinical studies. Epilepsia 2013; 54: 98-107. (Among 1049 adults participating in 3 controlled trials of eslicarbazepine [400, 800 or 1200 mg daily] for partial onset seizures, adverse events were dose dependent, the most common being dizziness, somnolence and headache and “very few patients had clinically significant abnormalities in liver function tests” [<1% in any treatment group]). 22882018
Gaitatzis A, Sander JW. The long-term safety of antiepileptic drugs. CNS Drugs 2013; 27: 435-55. (Review of the long term safety and adverse event profile of anticonvulsants mentions that valproate and felbamate can cause liver failure, but does no mention hepatotoxicity of other anticonvulsants). 23673774
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of indications and side effects of anticonvulsants; oxcarbazepine [but not eslicarbazepine] is discussed] which is approved as both monotherapy and add-on therapy of adults with partial seizures; discussion of adverse effects does not mention hepatotoxicity). 23348233
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to oxcarbazepine or eslicarbazepine). 23419359
Kaniwa N, Saito Y. The risk of cutaneous adverse reactions among patients with the HLA-A* 31:01 allele who are given carbamazepine, oxcarbazepine or eslicarbazepine: a perspective review. Ther Adv Drug Saf 2013; 4: 246-53. (Review of HLA associations [A*31:01 and B*15:02] with hypersensitivity reactions to carbamazepine and the carboxamines, which are metabolized differently and believed to have fewer side effects; cases of A*31:01 associated SJS/TEN have been linked to use of oxcarbazepine, but eslicarbazepine cases have not been reported). 25114785
Kaniwa N, Saito Y. Pharmacogenomics of severe cutaneous adverse reactions and drug-induced liver injury. J Hum Genet 2013; 58: 317-26. (Review of genetic associations with severe skin and liver injury from drugs, focusing upon allopurinol [B*58:01], abacavir and flucloxacillin [B*57:01] and lapatinib [DQA1*02:01]; the association of B*15:02 with SJS from carbamazepine has not been extended to its liver injury). 23635947
Kaniwa N, Sugiyama E, Saito Y, Kurose K, Maekawa K, Hasegawa R, Furuya H, et al.; Japan Pharmacogenomics Data Science Consortium. Specific HLA types are associated with antiepileptic drug-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in Japanese subjects. Pharmacogenomics 2013; 14: 1821-31. (Analysis of HLA types among 12 Japanese patients with SJS/TEN due to zonisamide, found five patients [42%] to have HLA-A*02:07 compared to 6.8% of controls). 24236482
Verrotti A, Loiacono G, Rossi A, Zaccara G. Eslicarbazepine acetate: an update on efficacy and safety in epilepsy. Epilepsy Res 2014; 108: 1-10. (Summary of the mechanism of action, pharmacokinetics, efficacy and safety of eslicarbazepine mentions that “there were no significant changes in clinical laboratory parameters”). 24225327
Eslicarbazepine acetate (Aptiom) for epilepsy. Med Lett Drugs Ther 2014; 56 (1443): 42-3. (Concise review of the mechanism of action, efficacy, safety, drug interactions and costs of eslicarbazepine shortly after its approval in the US mentions DRESS and Stevens Johnson syndrome [with hepatic toxicity] as potential adverse events). 24869714
Massot A, Gimenez-Arnau A. Cutaneous adverse drug reaction type erythema multiforme major induced by eslicarbazepine. J Pharmacol Pharmacother 2014; 5: 271-4. (41 year old woman with epilepsy developed a painful erythematous rash with oral involvement and lymphadenopathy 25 days after starting eslicarbazepine [bilirubin not given, ALT 226 U/L, GGT 263 U/L, eosinophilia 3900/μL], resolving within a few weeks of stopping therapy and starting prednisone). 25422574
Correia FD, Freitas J, Magalhães R, Lopes J, Ramalheira J, Lopes-Lima J, Chaves J. Two-year follow-up with eslicarbazepine acetate: a consecutive, retrospective, observational study. Epilepsy Res 2014; 108: 1399-405. (Among 152 patients with refractory epilepsy started on eslicarbazepine at a single referral center and followed for 2 years, adverse events occurred in 42% leading to discontinuation in half, the most common side effects being dizziness, somnolence, nausea, psychiatric syndromes, weight gain, diplopia and rash; no mention of ALT elevations or hepatotoxicity). 25060997
Villanueva V, Serratosa JM, Guillamón E, Garcés M, Giráldez BG, Toledo M, Salas-Puig J, et al. Long-term safety and efficacy of eslicarbazepine acetate in patients with focal seizures: results of the 1-year ESLIBASE retrospective study. Epilepsy Res 2014; 108: 1243-52. (In a retrospective analysis of 327 patients with focal seizures treated with eslicarbazepine at 12 hospitals in Spain during a 2 year period, rash was reported in 9 [2.7%] and transient ALT elevations in 1 [0.3%] patient). 24908564
Sperling MR, Harvey J, Grinnell T, Cheng H, Blum D; 045 Study Team. Efficacy and safety of conversion to monotherapy with eslicarbazepine acetate in adults with uncontrolled partial-onset seizures: a randomized historical-control phase III study based in North America. Epilepsia 2015; 56: 546-55. (Among 193 adults patients with poorly controlled partial onset seizures who were switched to monotherapy with eslicarbazepine, common side effects were dizziness, headache, fatigue, somnolence and nausea; no mention of ALT elevations or hepatotoxicity). 25689448
Jacobson MP, Pazdera L, Bhatia P, Grinnell T, Cheng H, Blum D; study 046 team. Efficacy and safety of conversion to monotherapy with eslicarbazepine acetate in adults with uncontrolled partial-onset seizures: a historical-control phase III study. BMC Neurol 2015; 15: 46. (Among 172 patients with poorly controlled partial onset seizures switched to monotherapy with eslicarbazepine and treated for at least 10 weeks, 11 patients developed a serious adverse event including one with DRESS syndrome, but “most clinical laboratory parameters were comparable between treatment groups” and there was no mention of ALT elevations or hepatotoxicity). 25880756
Sperling MR, Abou-Khalil B, Harvey J, Rogin JB, Biraben A, Galimberti CA, Kowacs PA, et al.; 304 Study Team. Eslicarbazepine acetate as adjunctive therapy in patients with uncontrolled partial-onset seizures: Results of a phase III, double-blind, randomized, placebo-controlled trial. Epilepsia 2015; 56: 244-53. (Among 653 patients with poorly controlled partial onset seizures who received adjunctive therapy with eslicarbazepine [800 or 1200 mg daily] or placebo for 12 weeks, the response rate was significantly better with the higher dose than with placebo, and “overall, changes in clinical laboratory parameters [other than serum sodium] were not substantially different between the three groups”). 25528898
Grunze H, Kotlik E, Costa R, Nunes T, Falcão A, Almeida L, Soares-da-Silva P. Assessment of the efficacy and safety of eslicarbazepine acetate in acute mania and prevention of recurrence: experience from multicentre, double-blind, randomised phase II clinical studies in patients with bipolar disorder I. J Affect Disord 2015; 174: 70-82. (Among 245 patients with acute mania treated with eslicarbazepine or placebo in two randomized controlled, short term trials, there were no liver related serious adverse events reported). 25484179
Ley M, Principe A, Jiménez-Conde J, Rocamora R. Assessing long-term effects of eslicarbazepine acetate on lipid metabolism profile, sodium values and liver function tests. Epilepsy Res 2015; 115: 147-52. (Among 108 patients treated with eslicarbazepine for an average of 2 years, there were no statistically significant changes in liver tests including ALT and AST). 26220393
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, but none to oxcarbazepine or eslicarbazepine). 25754159
Holtkamp M, McMurray R, Bagul M, Sousa R, Kockelmann E. Real-world data on eslicarbazepine acetate as add-on to antiepileptic monotherapy. Acta Neurol Scand 2016; 134: 76-82. (Among 247 adults treated in clinical practice with eslicarbazepine for at least 6 months, 57 [26%] had adverse events, 25 [12%] discontinued therapy because of side effects and 8 [4%] had serious adverse events, but none were liver related; no mention of ALT elevations). 26915469
Elger C, Koepp M, Trinka E, Villanueva V, Chaves J, Ben-Menachen E, Kowacs PA, et al. Pooled efficacy and safety of eslicarbazepine acetate as add-on treatment in patients with focal-onset seizures: Data from four double-blind placebo-controlled pivotal phase III clinical studies. CNS Neurosci Ther 2017; 23: 961-72. (Among 1703 patients enrolled in 4 controlled trials, adverse event rates were dose related leading to discontinuation in 9% [400 mg], 13% [800 mg] and 24% [1200 mg] of patients; no mention of ALT elevations or hepatotoxicity). 29030894
Villanueva V, Holtkamp M, Delanty N, Rodriguez-Uranga J, McMurray R, Santagueda P. Euro-Esli: a European audit of real-world use of eslicarbazepine acetate as a treatment for partial-onset seizures. J Neurol 2017; 264: 2232-48. (Among 2058 patients trated with eslicarbazepine in clinical practice, 34% reported adverse events which led to discontinuation in 14%, the most common side effects being dizziness [7%], fatigue [5%], somnolence [5%], and hyponatremia [3.5%]; no mention of ALT elevations or hepatotoxicity). 28921040
Gama H, Vieira M, Costa R, Graça J, Magalhães LM, Soares-da-Silva P. Safety profile of rslicarbazepine acetate as add-on therapy in adults with refractory focal-onset seizures: from clinical studies to 6 years of post-marketing experience. Drug Saf 2017; 40: 1231-40. (Analysis of safety data from 4 controlled trials and global safety databases discusses dizziness, somnolence, headaches, nausea, rash and hyponatremia, but no ALT elevations or hepatotoxicity). 28752473
Toledano R, Jovel CE, Jiménez-Huete A, Bayarri PG, Campos D, Gomariz EL, Giráldez BG, et al. Efficacy and safety of eslicarbazepine acetate monotherapy for partial-onset seizures: Experience from a multicenter, observational study. Epilepsy Behav 2017; 73: 173-9. (Among 117 Spanish patients with partial onset seizures treated with eslicarbazepine alone, 82% had improvement in seizure control and 18 [15%] had adverse events, but only 1 led to discontinuation, an allergic reaction; no mention of ALT elevations or hepatotoxicity). 28641170
Trinka E, Ben-Menachem E, Kowacs PA, Elger C, Keller B, Löffler K, Rocha JF, et al. Efficacy and safety of eslicarbazepine acetate versus controlled-release carbamazepine monotherapy in newly diagnosed epilepsy: A phase III double-blind, randomized, parallel-group, multicenter study. Epilepsia 2018; 59: 479-91. (Among 815 patients with new onset of seziures who were treated with esclicarbazepine or carbamazepine for 26 weeks, clinical response rates were similar in the two groups [71% and 76%] as were overall adverse event rates; no mention of ALT elevations or hepatotoxicity with either agent). 29369348

## OTHER REFERENCE LINKS

1. Recent References on Eslicarbazepine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Eslicarbazepine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Eslicarbazepine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eslicarbazepine)